# Natalizumab

## OVERVIEW

### Introduction

Natalizumab is a monoclonal antibody to human alpha-4 integrin which has potent immune suppressive activity and is used in the therapy of severe inflammatory bowel disease and relapsing multiple sclerosis. Natalizumab has been linked to rare instances of idiosyncratic acute liver injury that has features of autoimmunity and seen largely in patients being treated for multiple sclerosis.

### Background

Natalizumab (na" ta liz' ue mab) is a humanized monoclonal antibody to alpha-4 integrin, which binds avidly to the cellular adhesion molecule found on leukocytes blocking their ability to migrate to inflammatory foci. Inhibition of alpha-4 integrin activity leads to modulation of inflammatory pathways that are activated in autoimmune disorders. Natalizumab was shown to improve vision and motor function in patients with multiple sclerosis and to decrease inflammation, symptoms and relapses in patients with Crohn disease. Natalizumab was approved for use in the United States in 2005 and indications included severe Crohn disease and relapsing forms of multiple sclerosis. However, after its general availability, natalizumab was linked to several instances of progressive multifocal leukoencephalopathy (PML), a severe neurological condition which is believed to be due to reactivation of the JC virus in neural cells. Because of this severe complication (which is often fatal), natalizumab has been restricted in use and is available only by a special program that requires thorough assessment of risks and careful monitoring and reporting. Natalizumab is available in 15 mL vials of 300 mg under the brand name Tysabri. The recommended dose is 300 mg intravenously every 4 weeks. Common side effects include headache, fatigue, abdominal pain, nausea, diarrhea, arthralgia, vaginitis, upper and lower respiratory infections, and infusion reactions. Natalizumab is also capable of causing immune suppression, resulting in an increased susceptibility to severe viral and bacterial infections as well as immune reconstitution reactions when it is withdrawn. Other potential severe adverse reactions besides PML include herpes virus infections, hypersensitivity reactions, thrombocytopenia and bleeding, and hepatotoxicity.

### Hepatotoxicity

In large clinical trials, serum aminotransferase elevations occurred in an average of 5% of patients on natalizumab therapy and in a slightly lower, although similar proportion (~3%) of those who received placebo. While there were no individual case reports of liver injury attributed to natalizumab therapy, at least 59 instances of hepatic injury were reported to the Adverse Event Reporting System maintained by the FDA within 4 years of its initial approval. In a report summarizing six clinically apparent cases of liver injury attributable to natalizumab, all were associated with jaundice and all occurred in patients receiving natalizumab for multiple sclerosis. The onset of injury followed the initial infusion of natalizumab in 4 patients, and after 5 and 12 courses of treatment in the other two reported cases. The pattern of liver injury was hepatocellular in 5 cases and cholestatic in one. Several cases were accompanied by autoantibodies and were treated with corticosteroids (Case 1), but autoimmune features were not prominent and immunoallergic features (fever, rash, eosinophilia) were not reported. The clinical cases were moderate in severity and no patient developed acute liver failure or progressed to chronic liver injury or vanishing bile duct syndrome. Since that initial summary, several more case reports of clinically apparent liver injury attributable to natalizumab have appeared, many of which have features of autoimmunity and all arising in patients with multiple sclerosis. Many of the reported cases could be attributed to other therapies being given including isoniazid, beta interferon and high-dose pulse methylprednisolone therapy. Natalizumab can cause immune suppression and has been linked to bacterial and viral infections, but interestingly has not been reported to cause reactivation of tuberculosis or hepatitis B.

Likelihood score: B (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of liver injury caused by natalizumab is probably immunologically mediated, perhaps as a result of its effects on leukocyte function. Direct hepatotoxicity is unlikely because it is a monoclonal antibody and like other proteins it is taken up by cells by endocytosis and is metabolized into amino acids.

### Outcome and Management

The hepatotoxicity of natalizumab is usually moderate in severity and reversible with discontinuation of infusions. Recurrence of injury with a shorter latency and more severe course has been reported. In cases with persistent injury, the addition of prednisone has appeared to hasten recovery, but in most instances, corticosteroid therapy can ultimately be discontinued. There is little information about cross sensitivity to liver injury with other monoclonal antibodies or immune modulating agents, but in most instances other disease modifying agents have been tolerated without recurrence of injury, although many of these are capable of causing liver injury on their own.

Drug Class: Gastrointestinal Agents, Inflammatory Bowel Disease Agents; Monoclonal Antibodies, Multiple Sclerosis Agents

## CASE REPORT

### Case 1. Acute hepatocellular injury due to natalizumab.(1)

A 43 year old man with multiple sclerosis developed fatigue, fever and back pain 8 days after the fifth monthly dose of natalizumab. On hospital admission, he was found to have elevations in serum enzymes but was not jaundiced. Serum ALT was 410 U/L, AST 134 U/L, INR 1.17 and bilirubin 0.4 mg/dL. Over the next several days, his liver tests worsened, serum bilirubin peaking at 3.0 mg/dL. A liver biopsy showed acute lobular and portal hepatitis with mild fibrosis. Recovery was slow and prednisone was given. Natalizumab was not continued. Over the next 6 months liver tests returned to normal, whereupon natalizumab was restarted. After the second monthly infusion, however, he redeveloped fatigue and jaundice and liver tests were again abnormal: ALT 3494 U/L, AST 1259 U/L and bilirubin 13.4 mg/dL. The antinuclear antibody, which was negative during the first episode, was positive in titers >1:320. Natalizumab was again stopped and prednisone was given with subsequent improvement.

#### Key Points

Medication: | Natalizumab (300 mg infusions monthly for 5 months)
Pattern: | Hepatocellular (R=21.5)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 11 days after 5th monthly infusion initially; shortly after second monthly infusion on rechallenge 6 months later
Recovery: | 6 months initially, unknown upon rechallenge
Other medications: | Spirulina (food supplement), multivitamins, prednisone

#### Comment

This patient developed clinically apparent acute hepatocellular injury within 2 weeks of receiving his fifth monthly infusion of natalizumab for relapsing multiple sclerosis. The injury was moderate in severity, but slow to resolve. Liver histological features suggested an element of autoimmunity, and he was treated with prednisone but tolerated its withdrawal and had normal liver tests six months later. Upon reexposure, he redeveloped the liver injury with a shorter latency and with a more severe course. At this point, he was found to have high titers of ANA and prednisone was restarted. Although compatible with spontaneous autoimmune hepatitis (which has been reported in patients with multiple sclerosis), the timing of onset and recurrence of similar injury upon reexposure is reasonably convincing evidence that it was due to natalizumab, perhaps an autoimmune hepatitis that was triggered by the immunomodulatory therapy. This example was case 2 from the six case series reported by the FDA, which were based upon review of spontaneous adverse event reports during the first 4 years of general availability of natalizumab. The six cases were selected as the clinically apparent examples among a total of 59 separate reports of liver injury. The authors estimated the frequency of idiosyncratic clinically apparent liver injury from natalizumab to be 17 per 100,000 (~1 per 6000) exposed patients. Events occurring at this low rate are unlikely to be detected in premarketing studies. Interestingly, virtually all of the published cases of natalizumab-hepatotoxicity have occurred in patients with multiple sclerosis, an autoimmune condition in which spontaneous autoimmune hepatitis is not infrequent.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Natalizumab – Tysabri®

DRUG CLASS

Gastrointestinal Agents; Multiple Sclerosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=c5fdde91-1989-4dd2-9129-4f3323ea2962)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Natalizumab | 189261-10-7 | Monoclonal Antibody | Not Available

## CITED REFERENCE

1 Bezabeh S, Flowers CM, Kortepeter C, Avigan M. Clinically significant liver injury in patients treated with natalizumab. Aliment Pharmacol Ther 2010; 31: 1028-35.20163378

## ANNOTATED BIBLIOGRAPHY

References updated: 20 September 2025

Abbreviations: TNF, tumor necrosis factor; PML, progressive multifocal leukoencephalopathy.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, well before the availability of most antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents mentions the report of six cases of severe liver injury attributed to natalizumab report to the FDA Adverse Event Reporting System database).
Krensky AM, Azzi JR, Hafler DA. Immunotherapy for multiple sclerosis. Immunosuppressants and tolerogens. In, Brunton LL, Hilal-Dandan, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 649-652. (Textbook of pharmacology and therapeutics).
MacNaughton WK, Sharkey KA. Pharmacotherapy of inflammatory bowel disease. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 945-54. (Textbook of pharmacology and therapeutics).
Gordon FH, Lai CW, Hamilton MI, Allison MC, Srivastava ED, Fouweather MG, Donoghue S, et al. A randomized placebo-controlled trial of a humanized monoclonal antibody to alpha4 integrin in active Crohn's disease. Gastroenterology 2001; 121: 268-74. (Randomized controlled trial of natalizumab in 30 patients with mild-to-moderate Crohn's disease found no difference in side effects compared to placebo; no mention of ALT elevations or hepatotoxicity). 11487536
Miller DH, Khan OA, Sheremata WA, Blumhardt LD, Rice GP, Libonati MA, Willmer-Hulme AJ, et al.; International Natalizumab Multiple Sclerosis Trial Group. A controlled trial of natalizumab for relapsing multiple sclerosis. N Engl J Med 2003; 348: 15-23. (Randomized controlled trial of 6 months of natalizumab versus placebo in 213 patients with relapsing multiple sclerosis; adverse events were similar in natalizumab and placebo treated patients, but no mention of liver toxicity or ALT levels). 12510038
Keeley KA, Rivey MP, Allington DR. Natalizumab for the treatment of multiple sclerosis and Crohn's disease. Ann Pharmacother 2005; 39: 1833-43. (Literature review of safety and efficacy of natalizumab; abnormal liver tests were reported in 5% of natalizumab and 3% of placebo recipients). 16219898
Sandborn WJ, Colombel JF, Enns R, Feagan BG, Hanauer SB, Lawrance IC, Panaccione R, et al.; International Efficacy of Natalizumab as Active Crohn's Therapy(ENACT-1) Trial Group; Evaluation of Natalizumab as Continuous Therapy(ENACT-2) Trial Group. Natalizumab induction and maintenance therapy for Crohn's disease. N Engl J Med 2005; 353: 1912-25. (Summary of two controlled trials of natalizumab in 905 patients with active Crohn disease; total as well as serious adverse events were similar between the two groups; no mention of liver toxicity or ALT elevations). 16267322
Calabrese LH, Zein NN, Vassilopoulos D. Hepatitis B virus (HBV) reactivation with immunosuppressive therapy in rheumatic diseases: assessment and preventive strategies. Ann Rheum Dis 2006; 65: 983-9. (Review of the problem of reactivation of hepatitis B in patients with rheumatic diseases treated with immunosuppressive agents, with recommendations on prevention). 16627542
Polman CH, O'Connor PW, Havrdova E, Hutchinson M, Kappos L, Miller DH, Phillips JT, et al.; AFFIRM Investigators. A randomized, placebo-controlled trial of natalizumab for relapsing multiple sclerosis. N Engl J Med 2006; 354: 899-910. (Randomized controlled trial of natalizumab vs placebo in 942 patients with relapsing multiple sclerosis; fatigue and allergic reactions were more common in natalizumab treated patients; abnormal liver tests were reported in 5% of natalizumab vs 4% of placebo recipients). 16510744
Rudick RA, Stuart WH, Calabresi PA, Confavreux C, Galetta SL, Radue EW, Lublin FD, et al.; SENTINEL Investigators. Natalizumab plus interferon beta-1a for relapsing multiple sclerosis. N Engl J Med 2006; 354: 911-23. (Among 1171 patients with multiple sclerosis receiving interferon beta-1a who received the addition of natalizumab or placebo monthly for up to 2.5 years, the relapse rate was lower in those receiving natalizumab [23% vs 29%] and adverse event rates were similar including “abnormal liver function values” of <1% in both groups). 16510745
Sands BE, Kozarek R, Spainhour J, Barish CF, Becker S, Goldberg L, Katz S, et al. Safety and tolerability of concurrent natalizumab treatment for patients with Crohn's disease not in remission while receiving infliximab. Inflamm Bowel Dis 2007; 13: 2-11. (Randomized controlled trial of natalizumab vs placebo in 79 patients with Crohn disease who were receiving infliximab; adverse events were similar in the two groups and no clinically significant abnormalities were observed in laboratory parameters). 17206633
Targan SR, Feagan BG, Fedorak RN, Lashner BA, Panaccione R, Present DH, Spehlmann ME, et al.; International Efficacy of Natalizumab in Crohn's Disease Response and Remission(ENCORE) Trial Group. Natalizumab for the treatment of active Crohn's disease: results of the ENCORE Trial. Gastroenterology 2007; 132: 1672-83. (Randomized controlled trial of natalizumab vs placebo in 509 patients with active Crohn disease reported side effects of headache, nausea, fatigue, abdominal pain and dizziness; no mention of liver toxicity or ALT elevations). 17484865
Natalizumab (Tysabri) for Crohn's disease. Med Lett Drugs Ther 2008; 50: 34-6. (Concise summary of use of natalizumab for Crohn disease mentions that postmarketing hepatic toxicity had occurred). 18458669
Kaiser T, Moessner J, Patel K, McHutchison JG, Tillmann HL. Life threatening liver disease during treatment with monoclonal antibodies. BMJ 2009; 338: b508. (66 year old man with psoriasis was treated with efalizumab [anti-CD11a] and then adalimumab [anti-TNF], and 11 days later developed jaundice and severe hepatitis [bilirubin 9.1 rising to 52 mg/dL, ALT 549 U/L, Alk P 131 U/L], with HBsAg being detected and slow but eventual recovery). 19224957
Khokhar OS, Lewis JH. Hepatotoxicity of agents used in the management of inflammatory bowel disease. Dig Dis 2010; 28: 508-18. (Review of the hepatotoxicity of drugs used to treat inflammatory bowel disease focusing upon sulfasalazine, thiopurines, TNF inhibitors, and methotrexate). 20926880
Bezabeh S, Flowers CM, Kortepeter C, Avigan M. Clinically significant liver injury in patients treated with natalizumab. Aliment Pharmacol Ther 2010; 31: 1028-35. (Summary of 6 clinically apparent hepatic adverse events reported to the FDA over a 4 year period included 1 man and 5 women, ages 26 to 59 years, all with multiple sclerosis, injury arising after the first to 11th dose [bilirubin 4.5 to 16.1 mg/dL, ALT 753-3494 U/L, Alk P 46-1043 U/L], all resolving, all were icteric and symptomatic and 5 were hepatocellular; 3 had autoantibodies but immune features were not prominent: Case 1). 20163378
André MC, Pacheco D, Antunes J, Silva R, Filipe P, Soares de Almeida LM. Generalized skin drug eruption to natalizumab in a patient with multiple sclerosis. Dermatol Online J 2010; 16: 14. (29 year old man with multiple sclerosis developed generalized rash 30 days after starting natalizumab with abnormal liver tests [bilirubin not given, ALT 185 U/L, GGT 320 U/L, eosinophils 2150 cells/L], resolving within 3 weeks). 20579469
Aithal GP. Hepatotoxicity related to antirheumatic drugs. Nat Rev Rheumatol 2011; 7: 139-50. (Review of liver injury due to antirheumatic drugs discusses ALT elevations caused by anti-TNF agents and autoimmune hepatitis due to infliximab; no mention of natalizumab). 21263458
Van Assche G, Lewis JD, Lichtenstein GR, Loftus EV, Ouyang Q, Panes J, Siegel CA, et al. The London position statement of the World Congress of Gastroenterology on Biological Therapy for IBD with the European Crohn's and Colitis Organisation: safety. Am J Gastroenterol 2011; 106: 1594-602. (Systematic review of the literature and position statement on use and safety of anti-TNF agents and natalizumab in Crohn disease; no specific discussion of hepatotoxicity or reactivation of hepatitis B). 21844919
Mulero P, Caminero AB, Neri Crespo MJ, Fernández-Herranz R, Téllez Lara N. Latent tuberculosis seems not to reactivate in multiple sclerosis patients on natalizumab. J Neuroimmunol 2012; 243: 103-5. (Among 27 patients with multiple sclerosis treated with natalizumab, 6 had a reactive tuberculin test, but none had clinical evidence of reactivation during an average of 19 months of therapy; furthermore, worldwide at least 88,100 patients have been treated with natalizumab, but there have been no reports of tuberculosis associated with treatment in the literature). 22226471
Lisotti A, Azzaroli F, Brillanti S, Mazzella G. Severe acute autoimmune hepatitis after natalizumab treatment. Dig Liver Dis 2012; 44: 356-7. (31 year old woman developed ALT elevations after a first injection of natalizumab and jaundice after a second [bilirubin 23.1 mg/dL, ALT > 50 times ULN, "mild elevation" in Alk P, INR 2.6, ANA 1:160], with response to corticosteroid therapy and no recurrence on long term azathioprine). 22154948
Martínez-Lapiscina EH, Lacruz F, Bolado-Concejo F, Rodríguez-Pérez I, Ayuso T, Garaigorta M, Urman JM. Natalizumab-induced autoimmune hepatitis in a patient with multiple sclerosis. Mult Scler 2013; 19: 1234-5. (51 year old woman with multiple sclerosis on long term natalizumab [32 months] developed jaundice [bilirubin 3.4 mg/dL, ALT 1324 U/L, ALT 255 U/L] and responded to prednisone). 23069876
O'Connor P, Goodman A, Kappos L, Lublin F, Polman C, Rudick RA, Hauswirth K, et al. Long-term safety and effectiveness of natalizumab redosing and treatment in the STRATA MS Study. Neurology 2014; 83: 78-86. (Among 1094 patients with multiple sclerosis formerly enrolled in clinical trials of natalizumab and continued on therapy [300 mg every 4 weeks] for up to 5 years, 171 [16%] had at least one serious adverse event including 7 listed as "hepatobiliary" [without specific details] and 8 confirmed cases of PML). 24898925
Butzkueven H, Kappos L, Pellegrini F, Trojano M, Wiendl H, Patel RN, Zhang A, et al.; TYSABRI Observational Program (TOP) Investigators. Efficacy and safety of natalizumab in multiple sclerosis: interim observational programme results. J Neurol Neurosurg Psychiatry 2014; 85: 1190-7. (Among 4821 patients with multiple sclerosis being treated with natalizumab enrolled in a prospective observational program, 3599 continued on treatment, among whom there were 465 serious adverse events including 7 were abnormal liver tests [0.1% yearly], 18 cases of PML [0.4%] and 9 deaths, but none due to liver disease). 24532785
Hillen ME, Cook SD, Samanta A, Grant E, Quinless J, Rajasingham J. Fatal acute liver failure with hepatitis B virus infection during natalizumab treatment in multiple sclerosis. Neurol Neuroimmunol Neuroinflamm 2015; 2: e72. Erratum in Neurol Neuroimmunol Neuroinflamm 2015; 2: e97. (28 year old woman with multiple sclerosis on long term natalizumab [22 months] developed acute hepatitis B [bilirubin 1.0 mg/dL, ALT 1564 U/L, Alk P 70 U/L, HBsAg positive, IgM anti-HBc positive] that progressed to acute liver failure and death but it remained unclear whether this was acute hepatitis B or reactivation). 25815365
Antezana A, Sigal S, Herbert J, Kister I. Natalizumab-induced hepatic injury: A case report and review of literature. Mult Scler Relat Disord 2015; 4: 495-8. (26 year old woman with multiple sclerosis developed abnormal liver tests 2 weeks after a 2nd monthly infusion of natalizumab [bilirubin 24.9 mg/dL, ALT 856 U/L, Alk P 165 U/L] with slow but eventual recovery after stopping; review of literature identified 12 cases of acute liver injury due to natalizumab, half of which were “autoimmune” in character). 26590653
Drugs for multiple sclerosis. Med Lett Drugs Ther 2016; 58(1496): 71-4. (Concise review of the mechanism of action, clinical efficacy, safety, costs and relative role of the medications approved for use in multiple sclerosis mentions that beta interferon and natalizumab can cause clinically apparent liver injury and that fingolimod and teriflunomide are associated with frequent serum enzyme elevations). 27249095
Clerico M, Artusi CA, Di Liberto A, Rolla S, Bardina V, Barbero P, De Mercanti SF, et al. Long-term safety evaluation of natalizumab for the treatment of multiple sclerosis. Expert Opin Drug Saf 2017; 16: 963-72. (Review of the literature and adverse event databases identified 12 case reports of significant liver injury attributed to natalizumab and spontaneous reports of 22 cases of liver failure to the FDA). 28641055
Van Obberghen EK, Cohen M, Rocher F, Lebrun-Frenay C. Multiple immune disorders after natalizumab discontinuation: After the CIRIS, the SIRIS? Rev Neurol (Paris) 2017; 173: 222-4. (35 year old woman with multiple sclerosis stopped natalizumab therapy because of pregnancy and developed rash, diabetes, hypothyroidism and abnormal liver tests [values not given] most, but not all, of which resolved after delivery and restarting natalizumab, suggesting that the abnormalities were due to natalizumab withdrawal and reconstitution autoimmunity). 28372806
Kaufmann M, Haase R, Proschmann U, Ziemssen T, Akgün K. Real-world lab data in natalizumab treated multiple sclerosis patients up to 6 years long-term follow up. Front Neurol 2018; 9: 1071. (Results of routine laboratory results taken every 3 months for up to 6 years during natalizumab therapy in 120 patients with multiple sclerosis demonstrated that ALT and AST elevations were rare and usually mild; only one ALT value was above 3 times ULN, which was normal on retesting despite drug continuation). 30581413
Antonazzo IC, Poluzzi E, Forcesi E, Riise T, Bjornevik K, Baldin E, Muratori L, et al. Liver injury with drugs used for multiple sclerosis: a contemporary analysis of the FDA Adverse Event Reporting System. Mult Scler. 2019;25:1633-1640. PIMD: 30230957. (Among 4873 cases of severe liver injury attributed to agents used to treat multiple sclerosis reported to the FDA’s Adverse Event Reporting System between 2004 and 2016, the most frequently implicated agents were interferon-beta1a [n=2343], natalizumab [n=759], interferon beta1b [535], fingolimod [496], dimethyl fumarate [223], glatimer acetate [212] and teriflunomide [158]).
Butzkueven H, Kappos L, Wiendl H, Trojano M, Spelman T, Chang I, Kasliwal R, et al.; Tysabri Observational Program (TOP) Investigators. Long-term safety and effectiveness of natalizumab treatment in clinical practice: 10 years of real-world data from the Tysabri Observational Program (TOP). J Neurol Neurosurg Psychiatry 2020 Mar 31. [Epub ahead of print] (A long term observational study enrolled 6148 patients from 17 countries with multiple sclerosis as they started natalizumab with follow up for up to 11 years [median=5.2 years]; 829 patients [13.5%] had at least one serious adverse event including PML in 53 [0.9%], malignancy in 66 [1.1%] and hepatic events in 12 [0.2%] described as drug induced liver injury in 4, autoimmune hepatitis in 2 and acute liver failure, fulminant hepatitis, hepatitis and liver injury in 1 each: no specific details given). 32234967
Santoiemma PP, Maddur H, Moore CM. A case of drug-induced liver injury secondary to natalizumab. Case Reports Hepatol. 2020;2020:7976585.. (33 year old woman with multiple sclerosis developed fatigue and abdominal pain 1 day after restarting natalizumab which she had taken on and off for 3 years [bilirubin 2.8 mg/dL, ALT 3855 U/L, Alk P 70 U/L, ANA and SMA negative, INR 1.3] liver biopsy showing resolving hepatitis and liver tests improving over the next few weeks, but there was no further follow up). 32607262
Biolato M, Bianco A, Lucchini M, Gasbarrini A, Mirabella M, Grieco A. The disease-modifying therapies of relapsing-remitting multiple sclerosis and liver injury: a narrative review. CNS Drugs. 2021;35:861-880.. (Extensive review of the frequency and characteristics of hepatic injury associated with different disease modifying drugs for multiple sclerosis, mentions that elevations in serum aminotransferase levels arise in 5% of treated patients but are generally transient and mild, but that rare instances of acute liver injury with autoimmune features have been reported). 34319570
Cunha-Silva M, de Moraes PBS, de Carvalho PR, da Costa LBE, Assis-Mendonça GR, Lalli CA, Fernandes GCA, et al. Acute hepatitis with positive autoantibodies: a case of natalizumab-induced early-onset liver injury. Am J Case Rep. 2022;23:e936318.. (60 year old woman with multiple sclerosis developed jaundice the day after the first dose of natalizumab and shortly after pulse therapy with methylprednisolone [bilirubin 35.9 rising to 40.mg/dL, ALT 1790 U/L, Alk P 315 U/L, INR 1.27. IgG 552 mg/dL, ANA and SMA weakly positive] with response to prednisone therapy that was later withdrawal without recurrence of injury). 35767513
Ng HS, Zhu F, Zhao Y, Yao S, Lu X, Ekuma O, Evans C, Fisk JD, Marrie RA, Tremlett H. Adverse Events associated with disease-modifying drugs for multiple sclerosis: a multiregional population-based study. Neurology. 2024;102:e208006.. (Among 35,894 people from 4 Canadian provinces with multiple sclerosis and available health data there was an increased risk for incident chronic liver disease in patients on teriflunomide and acute liver injury in those on dimethyl fumarate, but rates of acute liver injury on natalizumab were too few [<6 in among 827 patient-years] to calculate risk). 38181306
Haggiag S, Giannelli V, Prosperini L, Cruciani A, Baiocchini A, Ruggieri S, Pellicelli A, et al. Concurrent management of multiple sclerosis and natalizumab-induced hepatitis with ofatumumab: a case report. Neurol Sci. 2024;45:5087-5089.. (30 year old woman with multiple sclerosis developed abnormal liver tests after the 4^th^ monthly infusion [bilirubin not provided, ALT 1857 U/L, GGT 71 U/L] with persistence of abnormalities while continuing natalizumab until prednisone was started but recurrence once corticosteroids were stopped, but resolution when she was switched to ofatumumab). 38861049
Dumitru-Martoiu MM, Petrescu S, Panea CA. Etiopathogenic and therapeutic considerations in a multiple sclerosis case with acute toxic hepatitis. Reports (MDPI). 2025;8:38. 40710829. (39 year old woman with multiple sclerosis on long-term natalizumab [7 years] and Ashwagandha for weight loss [1 month] took 4 to 5 tablets of acetaminophen [unknown dose] for 5 days for a upper respiratory infection and presented with jaundice and ecchymoses [bilirubin 7.6 mg/dL, ALT 2120 U/L, Alk P 247 U/L, R~25] with rapid recovery and normal ALT one week later suggesting that acetaminophen was the cause).
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. PMID: PIMD: 38992407. (Among 483 cases of idiosyncratic drug-induced liver injury enrolled in a prospective Latin American database over a 10 year period, none were attributed to interferon-beta but single instances of liver injury were due to natalizumab and fingolimod [personal communication]).
Rodriguez-Martinez JS, Serrano-Perez NH, Espinosa-Zarazua G, Cordova-Gallardo J. Natalizumab-induced autoimmune liver injury. Clin Res Hepatol Gastroenterol. 2025;49:102618.. (36 year old woman with multiple sclerosis developed jaundice 4 days after an initial infusion of natalizumab and 3 months after starting isoniazid for latent tuberculosis [bilirubin 17.3 mg/dL, ALT 2067 U/L, Alk P 208 U/L] resolving over the next 2 months with drug discontinuation and prednisone therapy). 40398815

## OTHER REFERENCE LINKS

1. Recent References on Natalizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Natalizumab/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Natalizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Natalizumab)